# Selective Androgen Receptor Modulators

## OVERVIEW

### Introduction

The selective androgen receptor modulators (SARMs) generally refer to a group of orally available, synthetic, nonsteroidal drugs that bind androgen receptors with tissue selective activity that preserves anabolic actions on muscle and bone, but with fewer and milder androgenic effects on prostate, skin, hair, liver and heart. Several such agents were developed and were evaluated as therapy of cancer cachexia, osteoporosis and bone and muscle wasting with aging, but none were approved for human use. Nevertheless, several SARMs are available in dietary supplements—either advertised as such or present as contaminants—for recreational use in bodybuilding and have been implicated in multiple cases of severe cholestatic jaundice that resembles anabolic steroid jaundice.

### Background

The selective androgen receptor modulators (SARMs) are a group of compounds that bind selectively to androgen receptors with anabolic but little or no androgenic activity. The selectivity is not due to variations in the androgen receptor but by tissue variation in the regulatory proteins (cofactors) that bind to and modulate the receptor signaling and preferentially activate androgen receptor function in bone and muscle. These small molecules were developed as agents to treat the muscle and bone loss that occurs with aging, malnutrition, cancer cachexia, and osteoporosis. The synthetic receptor modulators include at least 16 different orally available agents that often have multiple chemical or common names, and none of which are approved for use in humans by the FDA. The most studied and best known SARMs are ligandrol (LGD-4033, VK-5211), enobosarm (ostarine, MK-2866, GTx-024, S-22), and vosilasarm (RAD-140, testolone) [Table]. In experimental animals, these agents were shown to increase lean body mass and promote muscle growth with few androgenic effects. In short term clinical trials in healthy older adults with weight loss, SARMs were shown to increase body weight including lean body mass and to promote muscle growth with an attendant increase in physical strength. In studies of patients with cancer cachexia or osteoporosis, similar effects were achieved but there was little improvement in quality of life, clinical symptoms, physical strength, well-being or health. Because of the lack of significant improvements in clinical endpoints, none of the agents was approved for human use, and interest in their further development was tempered by the difficulties in obtaining full FDA approval.

Nevertheless, the effect of SARMs on muscle growth led to their recreational use for bodybuilding in healthy young men seeking to increase muscle mass and enhance masculine physical appearance. Black market SARMs became available on the internet and in some health and nutrition stores. These agents are synthesized by manufacturers that did not develop them initially and are not regulated by the FDA. Current product labels, if given, can be unreliable. SARMs are banned by the World Anti-Doping Agency, and screening has detected them in several competitive athletes who were then banned from competition. The FDA has published several clinical alerts about the dangers of using SARMs and their lack of proven safety and efficacy and has taken action against several producers of the black[struck: -] market products, but-SARMs remain available. The product labels often state that the drug is for research purposes only, so that the commercial producers can claim their sale is not in violation of FDA requirements about need for regulatory approval.

Table: Names and Dosages of SARMs Found in Recent Publications on Liver Injury

| Generic Name | Chemical Compound Name | Dose Range used in Clinical Trials | Dose Range in Cases of Liver Injury
1 | Ligandrol | LGD-4033, VK-5211 | 0.1-2.0 mg | 4-30 mg
2 | Enobosarm | MK-2866, S-22, GTx-024, Ostarine | 0.1-3.0 mg | 5-20 mg
3 | Vosilasarm | RAD-140, Testolone | 50-150 mg | 5-30 mg
4 | Andarine | GTx-007, S-4 | Not reported | 25-50 mg

Other less well described SARMs that have been developed and have not been approved for use in humans include GSK-2881078, S-23, YK-11, and LGD-3303. In addition, several commercial products advertised as effective in increasing muscle growth for bodybuilding that are sometimes mistakenly claimed to be SARMs include ibutamoren, stenabolic, and cardarine.

Ibutamoren also known as MK-677, LUM-201, and L-163,191 is a non-peptide agonist of the ghrelin receptor and a growth hormone secretagogue. It has been shown to increase secretion of growth hormone and insulin-like growth factor 1 (IGF-1) and to increase lean body mass. It is under evaluation as a therapy for growth hormone deficiency but has yet to be approved for use in humans by the FDA. Ibutamoren, like anabolic steroids and SARMS, is banned by the World Anti-Doping Agency.

Stenabolic also known as SR9009 is a non-peptide agonist of Rev-Erb α and Rev-Erbβ receptors which are involved in diurnal clock regulated genes and is thought to increase mitochondrial function and number independent of physical exercise. It is promoted as imitating physical activity and increasing muscle strength without exercise. It has not been approved for human use for any medical condition by the FDA. Stenabolic, like anabolic steroids and SARMS, is banned by the World Anti-Doping Agency.

Cardarine, also known as endurobol, GW-516, and GW-1516, is a peroxisome proliferator-activated receptor delta (PPARδ) agonist which in high doses increased physical performance in mice but also caused cancers in several organs including liver, skin, ovaries, and testes. Although several other PPARδ agonists are under evaluation as therapy of human diseases (including liver disease), cardarine has not been approved for use by the FDA and, like anabolic steroids and SARMS, is banned by the World Anti-Doping Agency.

YK-11 is a steroidal selective androgen receptor modulator and acts as a partial agonist of the androgen receptor but with unique downstream effects In addition, it is a myostatin inhibitor which promotes muscle growth. In cell cultures and animal models it increased muscle cell growth and had anabolic activity. YK-11 has not been approved for human use but has been used recreationally for body building. YK-11, like anabolic steroids and the nonsteroidal SARMS, is banned by the World Anti-Doping Agency.

Hepatotoxicity

In controlled clinical trials, the SARMs and the related nonsteroidal agents used to increase muscle mass were usually described as well tolerated with few mild-to-moderate adverse events. However, higher doses, which had the greatest effects on lean body mass, also had more frequent adverse effects with elevations in serum aminotransferases ranging from 5% to 21% and isolated ALT elevations requiring drug discontinuation. In the published clinical trials of SARMs there were no reports of clinically apparent liver injury with jaundice, but the duration of therapy was short, patients were monitored regularly and a small proportion discontinued therapy because of ALT elevations.

Recently, there have been multiple reports of clinically apparent liver injury with jaundice in patients taking SARMs for bodybuilding on their own and without medical supervision. The latency to onset was typically 2 to 3 months but ranged for a few weeks to a year. The presentation was usually with fatigue, anorexia, weight loss, abdominal pain, and pruritus followed by dark urine and jaundice. The clinical and enzyme pattern in cases resembled the typical injury caused by anabolic steroids. Initially, total bilirubin levels are only moderately elevated (4.0 to 8.0 mg/dL), with serum aminotransferases levels of 2 to 5 times the upper limit of normal (ULN), and alkaline phosphatase and GGT levels minimally elevated or normal. Subsequently, total and direct bilirubin levels rise while serum aminotransferase levels decrease, and alkaline phosphatase levels rise slightly. Thus, the initial laboratory test results pattern is dependent upon the duration of illness before presentation and test results. Liver biopsies showed canalicular cholestasis with mild inflammation and variable degrees of bile duct injury, often referred to as “bland cholestasis”. In some cases, there was mild sinusoidal dilatation. While the clinical patterns resembled those of anabolic steroid jaundice, there were differences, mostly in the degree of alkaline phosphatase and bilirubin elevations and in liver histology. However, like the injury due to anabolic steroids, the liver injury associated with SARM use is typically prolonged but is self-limited. Patients with severe jaundice (above 30 mg/dL) can develop an associated renal dysfunction with bilirubin casts, which may require temporary dialysis but is self-limited and resolves once serum bilirubin falls adequately. Some patients with prolonged jaundice and disabling symptoms were referred for liver transplantation, but almost all eventually improved spontaneously, and transplantation was avoided. Furthermore, with long term follow up, complete resolution of liver injury can be expected.

Likelihood score: B (likely cause of clinically apparent liver injury with jaundice).

### Mechanism of Injury

The mechanism by which SARMs cause liver injury is not known but is likely to be the result of excessive androgen receptor engagement and resultant interference with hepatocellular transport mechanisms for export of bilirubin and bile acids. Why some patients appear to be susceptible to this injury while others tolerate therapy is not known. Importantly, most patients with SARMs-related cholestatic jaundice appear to have taken high doses and sometimes taking multiple SARMs simultaneously (“Stacking”).

### Outcome and Management

The mild serum aminotransferase elevations that occur with SARM therapy are usually self-limited and may not require dose modification or discontinuation of therapy. Most patients taking SARMs for bodybuilding, however, are not under medical supervision and initial liver test abnormalities are not detected. Once jaundice is present, the injury has probably been ongoing for weeks or months. There are no known effective therapies for the liver injury from SARMS and the major goals should be discontinuation of all muscle building supplements and avoidance of other potential hepatotoxic exposure. Therapy with ursodiol and N-acetyl cysteine is often used but has not been shown to be effective. Isolated case reports of partial clinical responses to corticosteroids and use of molecular absorbent recirculation systems have been published but are of uncertain overall efficacy. Pruritus can be treated with cholestyramine, but the resin is generally not well tolerated and is of uncertain effectiveness. Antihistamines may be helpful in some cases particularly at bedtime. The use of intestinal bile acid transport inhibitors (“ibats”) has not been reported but theoretically might be of potential value. Reported cases of liver injury and jaundice with SARMs have often been prolonged but have invariably resolved. In view of this, liver transplantation should be avoided if possible. Restarting a SARM after clinically apparent liver injury is usually followed by recurrence of liver test abnormalities and should not be tried even with switching to other SARMs.

Drug Class: Androgens; Selective Androgen Receptor Modulators

## CASE REPORTS

### Case 1. Severe jaundice and prolonged cholestasis in a healthy young bodybuilder taking a combination of SARMs – Stacking.(1)

A 20 year old man developed nausea, abdominal pain, and fatigue followed by itching, dark urine and jaundice after taking a body building agent called “Freak Show: 5 SARM Stack” twice daily by mouth for about 5 weeks. The product was labeled as capsules containing MK-2866 (enobosarm or ostarine: 10 mg), GW-501516 (endurobol: 10 mg), MK-677 (Ibutamoren: 10 mg), LGD-4033 (ligandrol: 5 mg), and RAD-140 (vosilasarm or testolone: 6 mg). He specifically denied taking anabolic steroids. He was otherwise healthy without significant medical conditions, and on no medications chronically. He denied a history of liver disease, risk factors for viral hepatitis, or drug allergies. He drank alcohol socially and denied drug abuse. He stopped the supplement at the onset of symptoms. Four days later he sought medical care and was found to be icteric but without fever, rash, or evidence of chronic liver disease. During a two[struck: -] day hospitalization, blood tests showed a total bilirubin of 7.9 mg/dL, ALT 177 U/L, AST 112 U/L, alkaline phosphatase 100 U/L, and INR 1.05. Tests for acute hepatitis A, B, and C were negative as were routine autoantibodies (ANA, SMA, AMA). Despite having stopped the supplement, his serum bilirubin continued to rise and was 20 m/dL one week later and peaked at 41.5 mg/dL three weeks later (Table). He was readmitted to the hospital for further evaluation. Abdominal ultrasound was normal with no evidence of gallstones or biliary obstruction, which was further verified by computerized axial tomography (CAT) scan which showed normal appearing liver with no evidence of obstruction or biliary dilatation. A liver biopsy was not performed. Despite the severe hyperbilirubinemia, ALT levels fell into the range of 0.9 to 2.3 times ULN and alkaline phosphatase rose minimally with a maximal value of 174 U/L (1.5 times ULN). He had severe pruritus and was treated with only partial success with antihistamines and ursodiol. A month after onset he began to improve clinically[struck: ,] and by two months bilirubin levels had fallen to 7.5 mg/dL, by three months to 1.4 mg/dL, and by four months all liver tests were normal.

#### Key Points

Medication: | Freak Show: 5 SARM Stack
Pattern: | Mixed (R=3.4 initially)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 5 weeks
Recovery: | 4 months
Other medications: | None

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
6 weeks | 4 days | 177 | 106 | 7.9 | R = 3.4, 1 day hospitalization
7 weeks | 13 days | 57 | 124 | 20.0
| 18 days | 43 | 136 | 27.9
8 weeks | 20 days | 47 | 140 | 29.3
9 weeks | 27 days | 48 | 148 | 41.5
10 weeks | 1 month | 49 | 150 | 40.8 | Hospital readmission
11 weeks | 1.2 months | 45 | 174 | 38.8 | US and CT scans normal
3 months | 1.5 months | 64 | 153 | 22.0
| 1.8 months | 95 | 141 | 13.9
| 2 months | 117 | 111 | 7.5
| 2.2 months | 91 | 102 | 5.0
4 months | 2.7 months | 53 | 80 | 3.9
| 3 months | 41 | 73 | 3.1
5 months | 3.5 months | 30 | 64 | 1.4 | Jaundice resolved
6 months | 4 months | 24 | 54 | 0.6 | Liver tests normal
Normal Values | | <50 | <115 | <1.2

#### Comment

This is a classic example of bland cholestasis that in men is usually due to anabolic steroids but can also be caused by selective androgen receptor modulators with a similar pattern of clinical, biochemical, and histologic features. The latency was 1-2 months after starting a product called “Freak Show: 5 SARM Stacking.” The clinical presentation was with jaundice and pruritus with a distinctive early enzyme pattern of moderate serum aminotransferase elevations (4 to 10 times ULN) and normal or near normal alkaline phosphatase and GGT levels despite marked jaundice. Serum ALT and AST values fall rapidly into the near normal range despite worsening jaundice, which is prolonged and typically lasts 1-3 months with profound and disabling pruritus. Interestingly, alkaline phosphatase and GGT levels are normal or only minimally elevated, although more marked elevations might rise once bilirubin levels peak. Imaging of the liver is usually normal but is helpful to perform as it can rule out biliary obstruction. Most characteristic is liver histology which demonstrates moderate-to-severe canalicular cholestasis, with only mild or minimal inflammation and bile duct injury and without bile duct loss. Called “bland cholestasis”, it does not lead to hepatic failure, and INR levels are usually normal. Bilirubin levels above 30 mg/dL can lead to bilirubin cast nephropathy and some patients require temporary renal dialysis. But both the liver and the kidney injury are self-limited, and recovery is usually complete although it may require 1 to 6 months to fully resolve.

The SARMs listed on the product label of the “Freak Show” supplement were identified by chemical analysis of capsules provided by the patient. Furthermore, the capsules did not contain other contaminants such as prescription medications, herbal products, or anabolic steroids. Interestingly, only 3 of the 5 agents were actually SARMs. GW-501516 is a PPARδ agonist that was found to lead to muscle growth in mice while MK-677 is a ghrelin receptor agonist and growth hormone secretagogue that has also been shown to increase muscle mass in animal models. While SARMs are referred to as “selective”, the selectivity is relative and the agents appear to also simulate, to some degree, the androgen receptors in other organs such as skin, hair, liver, and heart. They also suppress the production of endogenous androgens and cause testicular atrophy and gynecomastia. These agents have replaced synthetic anabolic steroids as recreational drugs for body building. The injury is unlikely to be idiosyncratic or immune[struck: -] mediated and appears to be dose related.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Ligandrol – LGD-4033

Enobosarm – MK-2866 or ostarine

Vosilasarm – RAD-140 or testolone

DRUG CLASS

Androgens

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Drug | Enobosarm (MK-2866) | C_19_H_14_F_3_N_3_O_3_
Drug | Ligandrol (LGD-4033) | C_14_H_12_F_6_N_2_O
Drug | Vosilasarm (RAD-140) | C_20_H_16_ClN_5_O_2_ (https://pubchem.ncbi.nlm.nih.gov/#query=C20H16ClN5O2)
Drug | Andarine (GTx-007, S-4) | C_19_H_18_F_3_N_3_O_6_ (https://pubchem.ncbi.nlm.nih.gov/#query=C19H18F3N3O6)
Drug | GSK2881078 | C_14_H_13_F_3_N_2_O_2_S (https://pubchem.ncbi.nlm.nih.gov/#query=C14H13F3N2O2S) | CID: 86709174 (https://pubchem.ncbi.nlm.nih.gov/compound/86709174)

## CITED REFERENCES

1 Personal Communication: Raj Vuppalanchi.

## ANNOTATED BIBLIOGRAPHY

References updated: 20 September 2025

Abbreviations used: SARMs, Selective Androgen Receptor Modulators; ULN, upper limit of normal; PPARδ, peroxisome proliferator-activated receptor delta.

Zimmerman HJ. Anabolic steroids. Hormonal derivatives and other drugs used to treat endocrine disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 438-444. (Expert review of hepatotoxicity of published in 1999; discussed the bland cholestatic liver injury typical of anabolic steroids but was published long before the development of the selective androgenic receptor modulators (SARMs).
Snyder P. Androgens and the male reproductive tract. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Mohler ML, Bohl CE, Jones A, Coss CC, Narayanan R, He Y, Hwang DJ, et al. Nonsteroidal selective androgen receptor modulators (SARMs): dissociating the anabolic and androgenic activities of the androgen receptor for therapeutic benefit. J Med Chem. 2009;52:3597-617.. (Review of the development of selective androgen receptor modulators [SARMs] and the mechanism of selectivity, effects of the agents in vivo, in vitro, and in early clinical trials with the promise of future therapeutic benefits in muscle wasting and frailty found in chronic diseases, cachexia, osteoporosis, and hypogonadism). 19432422
Zilbermint MF, Dobs AS. Nonsteroidal selective androgen receptor modulator Ostarine in cancer cachexia. Future Oncol. 2009;5:1211-20.. (Review of the chemical structures, mechanisms of action, clinical effects and safety of nonsteroidal SARMs, focusing upon ostarine [enobosarm, GTx-24] including results from phase IIb clinical trials in which 159 patients with cancer received 1 or 3 mg of ostarine vs placebo orally once daily for 16 weeks which showed an increase in lean body mas [1.5 and 1.3 vs 0.1 kg] and chair climb power but not grip strength or gait speed, and ALT elevations occurred in 2 patients in all three groups). 19852734
Miller CP, Shomali M, Lyttle CR, O'Dea LS, Herendeen H, Gallacher K, Paquin D, et al. Design, synthesis, and preclinical characterization of the selective androgen receptor modulator (SARM) RAD140. ACS Med Chem Lett. 2010;2:124-9. (Description of the discovery of RAD140, a molecule with a high affinity for the androgen receptor with full activity on muscle but not prostate tissue). 24900290
Dalton JT, Barnette KG, Bohl CE, Hancock ML, Rodriguez D, Dodson ST, Morton RA, et al. The selective androgen receptor modulator GTx-024 (enobosarm) improves lean body mass and physical function in healthy elderly men and postmenopausal women: results of a double-blind, placebo-controlled phase II trial. J Cachexia Sarcopenia Muscle. 2011;2:153-161.. (Among 120 healthy adults [ages 48 to 79 years, both male and female] treated with GTx-024 [ostarine or enobosarm; 0.1, 0.3, 1 or 3 mg] or placebo by mouth once daily, there was a dose-related increase in lean body mass with increase in measures of muscle strength with the highest dose which was also associated with an increased rate of ALT elevations [21%] vs none with placebo and one patient on 3 mg daily discontinued therapy because of ALT elevations [4.2 times ULN]). 22031847
Dobs AS, Boccia RV, Croot CC, Gabrail NY, Dalton JT, Hancock ML, Johnston MA, et al. Effects of enobosarm on muscle wasting and physical function in patients with cancer: a double-blind, randomised controlled phase 2 trial. Lancet Oncol. 2013;14:335-45.. (Among 159 patients with cancer and weight loss treated with enobosarm [1 or 3 mg] or placebo once daily for up to 4 months, lean body mass increased more with enobosarm [1.5 and 1.0 kg vs 0.2 kg] while adverse event rates were similar in the 3 groups, and “increases in alanine aminotransferase concentrations were transient” and no patient discontinued therapy because of ALT elevations). 23499390
Basaria S, Collins L, Dillon EL, Orwoll K, Storer TW, Miciek R, Ulloor J, et al. The safety, pharmacokinetics, and effects of LGD-4033, a novel nonsteroidal oral, selective androgen receptor modulator, in healthy young men. J Gerontol A Biol Sci Med Sci. 2013;68:87-95.. (Among 76 healthy men treated with ligandrol [LGD-4033: 0.1, 0.3, or 1.0 mg] vs placebo once daily for 21 days, lean body mass increased in a dose-related fashion and serum testosterone declined with ligandrol therapy while adverse event rates were similar to those with placebo and “there were no clinically significant changes in liver enzymes”). 22459616
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to SARMs). 25754159
Bhattacharya I, Tarabar S, Liang Y, Pradhan V, Owens J, Oemar B. Safety, Pharmacokinetic, and Pharmacodynamic Evaluation After Single and Multiple Ascending Doses of a Novel Selective Androgen Receptor Modulator in Healthy Subjects. Clin Ther. 2016;38:1401-1416.. (Among 72 healthy male volunteers, ages 19 to 50 years, treated with PF-06260414 in single ascending doses of 1 to 400 mg or in multiple ascending doses of 3 to 100 mg once or twice daily, ALT elevations arose in 7 subjects, only one rising above 3 times ULN [peak value 343 U/L] leading to early discontinuation, with resolution of abnormalities in all and serious adverse events). 27085586
Temel JS, Abernethy AP, Currow DC, Friend J, Duus EM, Yan Y, Fearon KC. Anamorelin in patients with non-small-cell lung cancer and cachexia (ROMANA 1 and ROMANA 2): results from two randomised, double-blind, phase 3 trials. Lancet Oncol. 2016;17:519-531.. (Results of two controlled trials of anamorelin [a ghrelin receptor agonist: 100 mg] vs placebo once daily for 12 weeks in 979 patients with lung cancer and cachexia demonstrated significant increases in lean body mass [+1.0 vs -0.5 kg in the first; 0.7 vs -1.0 kg in the second] but no differences in changes of handgrip strength, no mention of ALT elevations or hepatotoxicity 26906526
Dalton JT. The long and winding road for selective androgen receptor modulators. Br J Clin Pharmacol. 2017;83:2131-2133.. (Commentary on the multiple trials of SARMs as therapy of cachexia and muscle wasting that have demonstrated significant increases in lean body mass but without accompanying improvements in physical function). 28621446
Clark RV, Walker AC, Andrews S, Turnbull P, Wald JA, Magee MH. Safety, pharmacokinetics and pharmacological effects of the selective androgen receptor modulator, GSK2881078, in healthy men and postmenopausal women. Br J Clin Pharmacol. 2017;83:2179-2194.. (Among 99 healthy men and post-menopausal women enrolled in a single ascending dose study or a 7 to 14 day multiple dose study of an experimental nonsteroidal SARM [GSK2881078], there were no serious adverse events in drug-treated cohorts while 4 subjects developed ALT elevations of 2 to 3 times ULN, two in association with rash and two in association with marked CPK elevations attributed to rigorous physical activity). 28449232
Van Wagoner RM, Eichner A, Bhasin S, Deuster PA, Eichner D. Chemical composition and labeling of substances marketed as selective androgen receptor modulators and sold via the Internet. JAMA. 2017;318:2004-2010.. (Among 44 SARMs products sold on the internet that were analyzed for chemical content, only 23 [52%] contained a known SARMs such as ostarine, ligandrol, or andarine and often not in the amount listed on the product label; while many other agents contained other unapproved drugs and 4 products contained no active ingredient). 29183075
Neil D, Clark RV, Magee M, Billiard J, Chan A, Xue Z, Russell A. GSK2881078, a SARM, produces dose-dependent increases in lean mass in healthy older men and women. J Clin Endocrinol Metab. 2018;103:3215-3224.. (Among 90 healthy older men and postmenopausal women volunteers treated with different doses of GSK2881078 for 28 or 56 days, the experimental SARM treated patients had greater increases in lean body mass with all dose levels [0.35 to 4 mg] and the drug was “generally well tolerated” and without serious adverse events, although ALT levels rose to above normal in over 50% of treated patients vs 13% of placebo controls] and above 5 times ULN in 3%). 29982690
Yatsu T, Kusakabe T, Kato K, Inouye Y, Nemoto K, Kanno Y. Selective androgen receptor modulator, YK11, up-regulates osteoblastic proliferation and differentiation in MC3T3-E1 cells. Biol Pharm Bull. 2018;41:394-398.. (Description of the in vitro effects of YK-11 on osteoblastic differentiation). 29491216
Solomon ZJ, Mirabal JR, Mazur DJ, Kohn TP, Lipshultz LI, Pastuszak AW. Selective androgen receptor modulators: current knowledge and clinical applications. Sex Med Rev. 2019;7:84-94.. (Review of clinical studies of SARMs and their promise for therapy of cachexia, muscle wasting, aging, and osteoporosis). 30503797
Christiansen AR, Lipshultz LI, Hotaling JM, Pastuszak AW. Selective androgen receptor modulators: the future of androgen therapy? Transl Androl Urol. 2020;9(Suppl 2):S135-S148.. (Thorough review of the status of SARMs as therapeutic agents for multiple conditions including osteoporosis, Alzheimer disease, cancer cachexia, osteoporosis, hypogonadisms, muscular dystrophy and sarcopenia; while shown to increase lean body mass, these agents have not demonstrated accompanying improvements in physical function which has tempered enthusiasm for achieving FDA approval for use). 32257854
Barbara M, Dhingra S, Mindikoglu AL. Ligandrol (LGD-4033)-induced liver injury. ACG Case Rep J. 2020;7:e00370.. (32 year old man developed fatigue, weight loss, and itching followed by jaundice 2 weeks after starting 10 mg of ligandrol daily [bilirubin 2.4 rising to 35.0 mg/dL, ALT 229 U/L, Alk P 88 rising to 425 U/L] liver biopsy showing cholestasis and mild inflammation and fibrosis, and jaundice lasting more than 3 months). 32637435
Barbara M, Dhingra S, Mindikoglu AL. Drug-induced liver injury associated with Alpha Bolic (RAD-140) and Alpha Elite (RAD-140 and LGD-4033). ACG Case Rep J. 2020;7:e00409.. (52 year old man developed itching and jaundice after taking SARMs products containing RAD140 (testalone, 10 mg) for 4 weeks followed by a product with RAD140 (7.5 mg) and LGD4033 (ligandrol, 5 mg) and presented with prolonged jaundice [bilirubin 34.5 mg/dL, ALT 46 U/L, Alk P 529 U/L, GGT 47 U/L], biopsy demonstrating canalicular cholestasis; followed by slow resolution with normal tests 3 months after stopping). 33062783
Fonseca GWPD, Dworatzek E, Ebner N, Von Haehling S. Selective androgen receptor modulators (SARMs) as pharmacological treatment for muscle wasting in ongoing clinical trials. Expert Opin Investig Drugs. 2020;29:881-891.. (Review of the status of clinical development of SARMs for treatment of muscle wasting, mentions six agents including ostarine [enobosarm], ligandrol, and testolone, most of which are in early phase 1 and 2 clinical trials, ostarine being in phase 3 trials in patients with cancer cachexia). 32476495
Machek SB, Cardaci TD, Wilburn DT, Willoughby DS. Considerations, possible contraindications, and potential mechanisms for deleterious effect in recreational and athletic use of selective androgen receptor modulators (SARMs) in lieu of anabolic androgenic steroids: A narrative review. Steroids. 2020;164:108753.. (Review of mechanisms of action, efficacy, and safety of SARMs in comparison to anabolic steroids and remaining challenges in defining their potential therapeutic roles). 33148520
Flores JE, Chitturi S, Walker S. Drug-induced liver injury by selective androgenic receptor modulators. Hepatol Commun. 2020;4:450-452.. (Two case reports: 24 and 49 year old men presented with jaundice 2 and 4 months after starting unknown doses of Ligandrol and RAD-140 [bilirubin 4.0 rising to 6.8 and 4.7 to 20.2 mg/dL, ALT 589 and 200 U/L, Alk P 197 and 111 U/L, GGT 62 and 60 U/L] with gradual improvement 2 to 4 months after stopping and toxicologic analysis demonstrating the SARMs without other contaminants). 32140660
Bedi H, Hammond C, Sanders D, Yang HM, Yoshida EM. Drug-induced liver injury from enobosarm (Ostarine), a selective androgen receptor modulator. ACG Case Rep J. 2021;8:e00518.. (Man in early 40s developed jaundice 2 months after starting an unknown daily dose of enobosarm for body building [bilirubin 20 rising to 40.3 mg/dL, ALT 112 U/L, Alk P 268 U/L, GGT 49 U/L]) resolving slowly over the ensuing 2-3 months). 34368386
Koller T, Vrbova P, Meciarova I, Molcan P, Smitka M, Adamcova Selcanova S, et al. Liver injury associated with the use of selective androgen receptor modulators and post-cycle therapy: Two case reports and literature review. World J Clin Cases. 2021;9:4062-4071.. (Two case reports; 19 and 28 year old men developed jaundice 2 and 3 months after starting unknown doses of ligandrol and ostarine [bilirubin 13.9 and 23.5 mg/dL, ALT 132 and 144 U/L, Alk P 92 and 92 U/L, GGT 25 and unknown], liver biopsies showing cholestasis with ductopenia and bile duct injury, resolution within 3 months of stopping). 34141767
Kintz P, Gheddar L, Paradis C, Chinellato M, Ameline A, Raul JS, Oliva-Labadie M. Peroxisome proliferator-activated receptor delta agonist (PPAR- δ) and selective androgen receptor modulator (SARM) abuse: clinical, analytical and biological data in a case involving a poisonous combination of GW1516 (cardarine) and MK2866 (ostarine). Toxics. 2021;9:251.. (43 year old man developed acute rhabdomyolysis shortly after taking a combination of cardarine, ostarine and a PPARδ agonist). 34678947
LoRusso P, Hamilton E, Ma C, Vidula N, Bagley RG, Troy S, Annett M, et al. A first-in-human phase 1 study of a novel selective androgen receptor modulator (SARM), RAD140, in ER+/HER2- metastatic breast cancer. Clin Breast Cancer. 2022;22:67-77.. (Among 22 postmenopausal women with metastatic breast cancer treated with escalating doses of RAD140 [50, 100, or 150 mg daily for at least 28 days] adverse events arose in all patients which included elevations in ALT in 46%, AST in 59%, and bilirubin in 27% 34565686
Cardaci TD, Machek SB, Wilburn DT, Heileson JL, Harris DR, Cintineo HP, Willoughby DS. LGD-4033 and MK-677 use impacts body composition, circulating biomarkers, and skeletal muscle androgenic hormone and receptor content: A case report. Exp Physiol. 2022;107:1467-1476.. (25 year old resistance training man started on LGD-4033 [ligandrol] and MK-677 [Ibutamoren] for 5 weeks and, while on therapy had an increase in both lean [3%] and fat [15%] mass, but decline in bone density and with elevations in serum ALT [20 to 61 U/L], total cholesterol [155 to 178 mg/dL], LDL cholesterol [90 to 126 mg/dL], triglycerides [51 to 71 mg/dL] and decline in serum testosterone [639 to 241 mg/dL] and HDL cholesterol [55 to 35 mg/dL], which reversed in part by 4 weeks after withdrawal of the SARMs although fat mass remained higher than baseline). 36303408
Leung K, Yaramada P, Goyal P, Cai CX, Thung I, Hammami MB. RAD-140 drug-induced liver injury. Ochsner J. 2022;22:361-365.. (24 year old man developed jaundice 2 months after starting RAD-140 in doses up to 15 mg daily [bilirubin 10.8 rising to 32.3 mg/dL, ALT 171 U/L, Alk P 151 U/L, GGT normal] liver biopsy showing canalicular cholestasis with minimal inflammation, with slow recovery). 36561105
Khan S, Fackler J, Gilani A, Murphy S, Polintan L. Selective androgen receptor modulator induced hepatotoxicity. Cureus. 2022;14:e22239.. (29 year old developed jaundice after taking 4 weeks of “a SARM supplement” [initial bilirubin 16.9 rising to 22.6 mg/dL, ALT 165 U/L, Alk P 213 U/L] with slow resolution by 3 to 4 months after stopping). 35340496
Weinblatt D, Roy S. Drug-induced liver injury secondary to enobosarm: a selective androgen receptor modulator. J Med Cases. 2022;13:244-248.. (31 year old man developed itching and dark urine after taking an unknown dose of enobosarm for 2 weeks [bilirubin 0.5 mg/dL, ALT 346 U/L, Alk P 123 U/L] with rapid recovery within 3 to 4 weeks). 35655632
Mohamed WT, Jahagirdar V, Fatima I, Ahmed MK, Jaber F, Wang K, Hassan A, et al. Selective androgen receptor modulators (SARMs)-induced liver injury: a case report and review of literature. Cureus. 2023;15:e35094.. (22 year old man developed jaundice 3 to 4 months after starting an unknown dose of RAD140 [testolone] for muscle building [bilirubin 5.0 rising to 31 mg/dL, ALT 400 U/L, Alk P 190 U/L] with slow recovery but bilirubin still 13.6 mg/dL when last seen, although “full recovery was expected”). 36945289
Mohideen H, Hussain H, Dahiya DS, Wehbe H. Selective androgen receptor modulators: an emerging liver toxin. J Clin Transl Hepatol. 2023;11:188-196.. (Review of SARMs and their potential for causing liver injury, summaries 12 published cases of cholestatic jaundice attributed to SARMs [ostarine, ligandrol, and testolone], all of which resolved after stopping without fatalities or liver transplant, clinical features resembling the jaundice caused by anabolic steroids). 36479151
Lee BK, Park BB, Bower RJ. Selective androgen receptor modulator-induced liver injury in active duty male. Mil Med. 2023;188(7-8):usac039.. (23 year old developed jaundice 3 months after starting 3 SARMs including ligandrol, testolone, and YK11, [bilirubin 29.2 rising to 36.4 mg/dL, ALT 148 U/L, Alk P 151 U/L] with slow recovery over following three months). 35253885
Arayangkool C, Gozun M, Tanariyakul M, Techasatian W, Leesutipornchai T, Nishimura Y. Bile cast nephropathy because of acute liver injury associated with selective androgen receptor modulators. ACG Case Rep J. 2023;10:e01105.. (27 year old developed jaundice 3 months after starting unknown amounts of 3 SARMs including ligandrol, testolone, and ostarine [bilirubin 43.3 mg/dL, ALT 52 U/L, Alk P 343 U/L] with renal dysfunction; liver biopsy showing canalicular cholestasis and renal biopsy showing bilirubin nephropathy, but ultimate recovery from both after stopping). 37501938
Mohan D, Rossiter H, Watz H, Fogarty C, Evans RA, Man W, Tabberer M, et al. Selective androgen receptor modulation for muscle weakness in chronic obstructive pulmonary disease: a randomised control trial. Thorax. 2023;78:258-266.. (Among 47 postmenopausal women and 49 adult men with chronic obstructive lung disease treated with GSK2881078 [1 or 2 mg daily], an experimental SARM, or placebo for 13 weeks along with a home-exercise program, lean body mass increased more with the drug, and muscle strength increased slightly more in men, but physical activity and symptoms did not differ between the two groups and 2 patients developed ALT elevations [7 times ULN] which resolved with stopping). 36283827
Ladna M, Taylor K, Bhat A, Dideban B. Idiosyncratic drug-induced liver injury related to use of novel selective androgen receptor modulator RAD140 (Testalone): a case report. J Med Case Rep. 2023;17:134.. (26 year old man developed nausea and abdominal pain followed by jaundice after taking unknown doses of RAD140 [testalone] daily for at least 2 months [bilirubin 4.9 mg/dL, ALT 243 U/L, Alk P and GGT normal] which resolved within a month of stopping). 36978171
Vignali JD, Pak KC, Beverley HR, DeLuca JP, Downs JW, Kress AT, Sadowski BW, et al. Systematic review of safety of selective androgen receptor modulators in healthy adults: implications for recreational users. J Xenobiot. 2023;13:218-236.. (Extensive review of the published literature on the safety of SARMs in healthy adults excluding studies in patients with muscle wasting, cancer cachexia, or sarcopenia, identified 15 case reports of liver injury, including 8 from LGD-4033, 6 RAD-149, 3 ostarine, 1 YK11, 1 unknown, and several with multiple agents; among 17 clinical trials of 13 different SARMs in 2136 patients, rates of ALT elevations ranged from 0% to 63%, but most elevations were mild and rapidly reversed with or without stopped, and none were accompanied by bilirubin elevations or jaundice). 37218811
Hahamyan HA, Basaria S. Selective androgen receptor modulators-transformative drugs or heralds of the next drug epidemic? JAMA. 2024;331:1359-1360.. (Commentary on the growing recreational use of SARMs as unregulated drugs of questionable safety and efficacy used to enhance body image with unknown risks of heart and liver disease). 38526456
Leciejewska N, Jędrejko K, Gómez-Renaud VM, Manríquez-Núñez J, Muszyńska B, Pokrywka A. Selective androgen receptor modulator use and related adverse events including drug-induced liver injury: Analysis of suspected cases. Eur J Clin Pharmacol. 2024;80:185-202.. (Review of the adverse side effects of SARMs and review of 21 published cases of liver injury attributed to their use concludes that “promoting SARMS as a safe alternative to other anabolic compounds … poses a risk to public health”). 38059982
Perananthan V, George J. Severe liver injury following use of RAD-140, a selective androgen receptor modulator, for body building. Aust Prescr. 2024;47:26-28.. (43 year old white male developed jaundice and pruritus 2 months after starting RAD-140 [unknown dose] for body building [bilirubin 15.3 rising to 41.4 mg/dL, ALT 158 U/L, Alk P 150 U/L, GGT 62 U/L, INR 1.5] with prolonged jaundice and liver tests abnormalities resolving 5 months after stopping). 38444893
Nash E, Nicoll A, Batt N, George J, Perananthan V, Prince D, Wallace M, et al. Drug-induced liver injury from selective androgen receptor modulators, anabolic-androgenic steroids and bodybuilding supplements in Australia. Aliment Pharmacol Ther. 2024;59:953-961.. (Among 40 cases of drug-induced liver injury attributed to body building agents seen at 9 Australian referral centers between 2017 and 2023, 18 were due to anabolic steroids, 14 to SARMs [ligandrol 5, testalone 5, ostarine 2, unknown 2], and 8 to other supplements; clinical, and biochemical features of anabolic steroid cases were similar to those of SARMs cases). 38372012
Mertens JE, Bömmer MTC, Regier MB, Gabriëls G, Pavenstädt H, Grünewald I, Horvath J, et al. Liver injury after selective androgen receptor modulator intake: a case report and review of the literature. Z Gastroenterol. 2024;62:935-943.. (24 year old man developed pruritus and jaundice after taking ostarine [ML-2866] for one week [bilirubin 31.1 mg/dL, ALT 95 U/L, Alk P 220 U/L, GGT 33 U/L], liver biopsy showing bland cholestasis, treated with a molecular adsorbent recirculation system (MARS) but still required 6 months for full recovery). 37871633
Demangone MR, Abi Karam KR, Li J. Selective androgen receptor modulators leading to liver injury: a case report. Cureus. 2024;16:e67958.. (29 year old man developed weight loss and jaundice 2 to 3 months after starting testalone [20 mg daily] [bilirubin 8.8 rising to 12.2 mg/dL, ALT 100 U/L, Alk P 152 U/L] resolving over the next 1-2 months). 39328701
Labban H, Kwait B, Paracha A, Islam M, Kim DO. LGD-4033 and a case of drug-induced liver injury: exploring the clinical implications of off-label selective androgen receptor modulator use in healthy adults. Cureus. 2024;16:e69601.. (52 year old man developed weight loss, pruritus, and jaundice 2-3 months after starting ligandrol in higher than recommended doses, and jaundice persisted for 2 weeks despite stopping [bilirubin 17 mg/dL, ALT 207 U/L, Alk P 196 U/L], resolving 1-2 months afterwards). 39421081
Habeb B, Valdes O, Khair S, Thomson ES. Silent threats to the liver: acute hepatotoxicity attributed to selective androgen receptor modulators (SARMs). Cureus. 2025;17:e85500.. (27 year old man developed jaundice having used an unknown dose of RAD-140 twice daily for the previous year [bilirubin 9.6 rising to 27 mg/dL, ALT 409 U/L, Alk P 131 U/L], with improvement a month after stopping the SARM but bilirubin still elevated). 40625511
Govil D, Afram R, Alkhafaji A, Woods E, Affas S. When gains go wrong: a case of selective androgen receptor modulator-related liver injury. Cureus. 2025;17:e87376.. (40 year old man developed jaundice shortly after starting Stenabolic [Rev-ErbA agonist] for body building [bilirubin 7.7 mg/dL, ALT 108 U/L, Alk P 101 U/L] with improvement on stopping but scant follow up information). 40765588
Niazi B, Quach B, Fisher K, Peeraphatdit T. Cholestatic drug-induced liver injury from rad-140 successfully treated with corticosteroids. ACG Case Rep J. 2025;12:e01803.. (42 year old man developed pruritus and jaundice 8 weeks after starting an unknown dose of RAD-140 for muscle growth [bilirubin 20.2 mg/dL, ALT 76 U/L, Alk P 172 U/L, GGT 44 U/L], persistence of marked jaundice led to therapy with prednisone and subsequent prompt improvement, bilirubin falling to normal 3 months after stopping SARM). 40761329
Barrios MM, Deconinck E, Vanhee C, Lamme EK, 't Hart-Bakker I, Syversen PV, Bøyum O, et al. SARMs, metabolic modulators and growth hormone secretagogues in suspected illegal medicines, bought as sport performance enhancers: a retro- and prospective study within the GEON. Drug Test Anal. 2025; 17: 2078-2085.. (A European market surveillance study of illegal SARMs products identified by laboratories in 13 countries identified 354 results, most frequently ibutamoren [n=62], ligandrol [48], ostarine [46], cardarine [45], andarine [34], RAD-140 [26], SR9009 [Stenabolic: 25], YK-11 [21], meldonium [14], and S23 [10]). 40551438

## OTHER REFERENCE LINKS

1. Recent References on Selective Androgen Receptor Modulators: from PubMed.gov (https://pubmed.ncbi.nlm.nih.gov/?term=selective+androgen+receptor+modulators+)

2. Trials on Selective Androgen Receptor Modulators: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acitretin)